# Cabozantinib

## OVERVIEW

### Introduction

Cabozantinib is an orally available kinase inhibitor and antineoplastic agent that is used in treatment of advanced kidney, liver, thyroid and neuroendocrine cancers. Cabozantinib is associated with a high rate of serum enzyme elevations during treatment and has been linked to rare instances of clinically apparent liver injury, particularly when it is combined with an immune checkpoint inhibitor.

### Background

Cabozantinib (ka" boe zan' ti nib) is an orally available, small molecule, multi-kinase inhibitor with activity against hepatocyte growth factor receptor (MET), vascular endothelial growth factor receptor 2 (VEGFR-2), and rearranged during transfection (RET), cell surface tyrosine kinase receptors which are overexpressed in several forms of cancer. Cabozantinib has been evaluated as therapy of several advanced and metastatic carcinomas and has shown efficacy in medullary thyroid, renal cell, hepatocellular, differentiated thyroid, and neuroendocrine cancers. Cabozantinib received accelerated approval for use in the United States in 2012 for therapy of refractory medullary thyroid cancer. Indications were expanded in 2016 to include advanced renal cell carcinoma, and subsequently to hepatocellular carcinoma previously treated with sorafenib (2019), advanced renal cell carcinoma in combination with nivolumab (2021), differentiated thyroid cancer (2021), and pancreatic and extrapancreatic neuroendocrine tumors (2025), the last three in adults and in children above the age of 12 years. For therapy of medullary thyroid cancer, cabozantinib is available as capsules of 20 and 80 mg under the brand name Cometriq, and the usual adult dose is 140 mg once daily. For the other indications it is available as tablets of 20, 40 and 60 mg under the brand name Cabometyx, and the usual adult dose is 60 mg once daily, reduced to 40 mg once daily when it is combined with nivolumab and in patients with moderate liver impairment. Common side effects include diarrhea, fatigue, nausea, constipation, anorexia, weight loss, hand-foot syndrome, stomatitis, hypertension, change in hair color, thrombocytopenia, neutropenia, anemia, rash and fever. Other uncommon, but potentially severe side effects include hemorrhage, gastrointestinal perforation and fistula formation, thrombotic events including myocardial infarction, stroke and arterial thromboses, heart failure, hypertensive crisis, adrenal insufficiency, proteinuria, osteonecrosis of the jaw, impaired wound healing, posterior leukoencephalopathy, thyroid dysfunction and embryo-fetal toxicity.

### Hepatotoxicity

In large clinical trials of cabozantinib, elevations in serum aminotransferase levels were common, ALT elevations arising in 45% to 68% of patients and AST elevations in 48% to 74%, and in up to 97% of patients in small trials. Values greater than 5 times the upper limit of normal (ULN) were less frequent, occurring in 2% to 11% of recipients. Serum alkaline phosphatase elevations were also common, arising in ~35% of patients and rising above 5 times ULN in 1% to 3%. The elevations were usually transient and asymptomatic and resolved with dose reduction or temporary interruption of therapy. Despite the high rate of serum enzyme elevations, cases of clinically apparent liver injury with jaundice were not reported in the preregistration trials of cabozantinib given by itself. Cholestatic hepatitis is listed in the product label as an uncommon adverse reaction, arising in less than 1% of patients.

Both the frequency and the severity of liver test abnormalities were greater when cabozantinib was combined with immune checkpoint inhibitors. In clinical trials as well as observation studies of cabozantinib and nivolumab, liver test abnormalities arose in 37% to 63% of patients with of recipients, and ALT elevations above 5 times ULN in 11% to 17%, rates higher than reported with cabozantinib alone. Most abnormalities resolved with dose reduction or temporary interruption of cabozantinib alone and did not require corticosteroids. Many patients tolerated resumption of therapy.

A single instance of prolonged cholestatic hepatitis evolving into vanishing bile duct syndrome has been described during combination cabozantinib and nivolumab therapy. In such cases, the contribution of each component is often unclear, but they may be additive or synergistic in causing liver injury, the check point inhibitor breaking tolerance to a toxic or immunogenic metabolic intermediate of the kinase inhibitor. As a consequence, a hepatotoxicity warning has been added to the product label for cabozantinib, and measurement of liver tests before and periodically during treatment is now recommended when it is given with nivolumab. Nevertheless, there have been only rare reports of clinically apparent liver injury attributed to cabozantinib alone.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanisms of liver injury accounting for serum enzyme elevations during cabozantinib therapy are not known, but may be a direct effect of inhibition of cellular kinases by this multi-specific tyrosine kinase inhibitor. Cabozantinib is metabolized in the liver, predominantly by the cytochrome CYP 3A4 and liver injury may be due to a toxic or immunogenic intermediate of its metabolism. Cabozantinib is susceptible to drug-drug interactions and the effects of CYP 3A4 inhibitors and inducers. The more frequent and severe injury that occurs when cabozantinib is combined with an immune checkpoint inhibitor is likely to be at least partly immune mediated.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. Clinically apparent liver injury should prompt immediate interruption of cabozantinib therapy. The product label recommends measuring liver tests before starting and periodically during treatment when cabozantinib is given with nivolumab. Most abnormalities resolve with dose reduction or interruption alone and patients have generally tolerated resumption of cabozantinib at a lower dose. corticosteroids should be reserved for persistent injury or when the injury is believed to be immune mediated. There is little information on cross reactivity in risk for hepatic injury between cabozantinib and other protein kinase inhibitors.

Drug Class: Antineoplastic Agents; Protein Kinase Inhibitors

Other Drugs in the Subclass: Axitinib, Lenvatinib, Regorafenib, Sorafenib, Sunitinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cabozantinib – Cometriq®, Cabometyx®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cabozantinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cabozantinib | 849217-68-1 | C28H24FN3O5 | SID: 135267839

## ANNOTATED BIBLIOGRAPHY

References updated: 22 August 2026

Abbreviations used: ULN, upper limit of normal; CYP, cytochrome P450; MET, hepatocyte growth factor receptor; VEGFR-2, vascular endothelial growth factor receptor 2; RET, rearranged during transfection.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of kinase inhibitors such as cabozantinib).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556-7. (Review of hepatotoxicity of cancer chemotherapeutic agents; cabozantinib is not discussed).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=3850cce2-6137-42e5-a792-d318c4a4b3b5 (The 2025 product label has a hepatotoxicity warning that rates of ALT elevations above 5 times ULN are more frequent with the combination of cabozantinib and nivolumab [11%] than with cabozantinib alone [1% to 5%], and states that patients receiving the combination should have liver tests monitored before and periodically during treatment).
Elisei R, Schlumberger MJ, Müller SP, Schöffski P, Brose MS, Shah MH, Licitra L, et al. Cabozantinib in progressive medullary thyroid cancer. J Clin Oncol. 2013;31:3639-3646. (Among 320 patients with progressive, metastatic medullary thyroid cancer treated with cabozantinib or placebo, progression-free survival increased from 4 to 11 months with cabozantinib, but adverse side effects were common and sometimes severe including diarrhea, fatigue and hand-foot syndrome, and ALT elevations occurred in 86% of treated patients versus 41% of controls, and above 5 times ULN in 6% vs 2%, although there were no instances of “drug-induced severe liver injury”). 24002501
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. 2015;148:1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5.5%] were attributed to antineoplastic agents, of which 9 [1%] were tyrosine kinase inhibitors including imatinib [5], lapatinib [2], cediranib, and regorafenib [1 each], but none were attributed to cabozantinib). 25754159
Choueiri TK, Escudier B, Powles T, Mainwaring PN, Rini BI, Donskov F, Hammers H, et al.; METEOR Investigators. Cabozantinib versus everolimus in advanced renal-cell carcinoma. N Engl J Med. 2015;373:1814-1823. (Among 658 patients with progressive, metastatic renal cell carcinoma treated with cabozantinib [60 mg] vs everolimus [10 mg] daily, progression-free and overall survival were greater with cabozantinib, with which side effects were frequent including moderate-to-severe diarrhea, fatigue and hand-foot syndrome with ALT elevations in 16% vs 2% which were above 5 times ULN in 6% vs <1%; no mention of clinically apparent liver injury or serious liver related adverse events). 26406150
Choueiri TK, Escudier B, Powles T, Tannir NM, Mainwaring PN, Rini BI, Hammers HJ, et al.; METEOR investigators. Cabozantinib versus everolimus in advanced renal cell carcinoma (METEOR): final results from a randomised, open-label, phase 3 trial. Lancet Oncol. 2016; 17:917-927. (Among 658 patients with advanced renal cell carcinoma treated with cabozantinib [60 mg] or everolimus [10 mg] once daily, overall survival was greater with cabozantinib [21 vs 19 months] and moderate-to-severe side effects of cabozantinib included hypertension, diarrhea, nausea, fatigue, anorexia and hand-foot syndrome, while ALT elevations occurred in 14% of patients and were above 5 times ULN in 2.4%). 27279544
Neal JW, Dahlberg SE, Wakelee HA, Aisner SC, Bowden M, Huang Y, Carbone DP, et al.; ECOG-ACRIN 1512 Investigators. Erlotinib, cabozantinib, or erlotinib plus cabozantinib as second-line or third-line treatment of patients with EGFR wild-type advanced non-small-cell lung cancer (ECOG-ACRIN 1512): a randomised, controlled, open-label, multicentre, phase 2 trial. Lancet Oncol. 2016;17:1661-1671. (Among 119 patients with advanced non-small cell lung cancer treated with cabozantinib or erlotinib or both, progression-free survival was greater with cabozantinib among whom AST elevations occurred in 15%, all being less than 5 times the upper limit of normal). 27825638
Drilon A, Rekhtman N, Arcila M, Wang L, Ni A, Albano M, Van Voorthuysen M, et al. Cabozantinib in patients with advanced RET-rearranged non-small-cell lung cancer: an open-label, single-centre, phase 2, single-arm trial. Lancet Oncol. 2016;17:1653-1660. (Among 26 patients with non-small cell lung cancer and RET rearrangement treated with cabozantinib [60 mg once daily], partial responses occurred in 7 patients, almost all patients had side effects, most commonly diarrhea, hand-foot syndrome, fatigue and ALT elevations [97%] which were above 5 times ULN in 8%; 19 patients [73%] required dose reductions, one [4%] for ALT elevations). 27825636
In brief: Cabozantinib (Cabometyx) for advanced renal cell carcinoma. Med Lett Drugs Ther. 2016;58(1499):e97. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of cabozantinib shortly after its approval for renal cell carcinoma, does not mention ALT elevations or hepatotoxicity). 27403787
Abou-Alfa GK, Meyer T, Cheng AL, El-Khoueiry AB, Rimassa L, Ryoo BY, Cicin I, et al. Cabozantinib in patients with advanced and progressing hepatocellular carcinoma. N Engl J Med. 2018;379:54-63. (Among 707 patients with advanced, sorafenib-refractory hepatocellular carcinoma treated with cabozantinib [60 mg daily] vs placebo, median survival was 10 vs 8 months, while ALT elevations arose in 17% vs 5% which were above 5 times ULN in 5% vs 2% and bilirubin elevations occurred in 10% vs 7%, some occurrences being possibly due to progression of the underlying cirrhosis and liver cancer). 29972759
Choueiri TK, Powles T, Burotto M, Escudier B, Bourlon MT, Zurawski B, Oyervides Juárez VM, et al.; CheckMate 9ER Investigators. Nivolumab plus cabozantinib versus sunitinib for advanced renal-cell carcinoma. N Engl J Med. 2021;384:829-841. (Among 651 patients with advanced renal cell carcinoma treated with cabozantinib and nivolumab vs sunitinib alone, progression free survival was 17 vs 8 months, while overall adverse event rates were similar, but ALT elevations above 5 times ULN were more frequent with the combination [10% vs 4%];no mention of clinical apparent liver injury). 33657295
Brose MS, Robinson B, Sherman SI, Krajewska J, Lin CC, Vaisman F, Hoff AO, et al. Cabozantinib for radioiodine-refractory differentiated thyroid cancer (COSMIC-311): a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet Oncol. 2021;22:1126-1138. (Among 187 patients with radioiodine-refractory thyroid cancer treated with cabozantinib [60 mg] or placebo once daily, an objective response occurred in 15% vs none, while serious adverse events arose in 16% vs 2%, and ALT elevations arose in 24% vs 2%, but only one on cabozantinib was above 5 times ULN). 34237250
Gourari K, Catherine J, Garaud S, Kerger J, Lepida A, Georgala A, Lebrun F, et al. A rare case of hepatic vanishing bile duct syndrome occurring after combination therapy with nivolumab and cabozantinib in a patient with renal carcinoma. Diagnostics (Basel). 2022;12:539. (58 year old man with metastatic renal cell carcinoma developed jaundice and a pruritic rash one month after adding cabozantinib [40 mg daily] to nivolumab that he had received for 8 months [bilirubin 28 mg/dL, ALT 1137 U/L, Alk P 805 U/L], liver biopsy showing centrilobular necrosis and cholangitis and, 5 weeks later, severe loss of the interlobular bile ducts, with slow resolution over 7 months on mycophenolate and ursodiol after corticosteroids had failed). 35204627
Chan JA, Geyer S, Zemla T, Knopp MV, Behr SC, Pulsipher S, Ou FS, et al. Phase 3 trial of cabozantinib to treat advanced neuroendocrine tumors. N Engl J Med. 2025;392:653-665. (Among 298 patients with refractory, advanced pancreatic or extrapancreatic neuroendocrine tumors treated with cabozantinib [60 mg] or placebo daily, progression free survival was 8 and 14 vs 4 months, while adverse events arising in more than half of treated patients included fatigue, diarrhea, hypertension, and ALT elevations, which arose in 59% vs 18% and were above 5 times ULN in 1% vs none). 39282913
Horiuchi T, Nishimura K, Nakamura K, Nemoto Y, Ishiyama Y, Katsurayama N, Toki D, et al. High real-world incidence of hepatic dysfunction from cabozantinib plus nivolumab for Japanese patients with metastatic renal cell carcinoma. Jpn J Clin Oncol. 2025;55:947-953. (Among 48 Japanese patients with metastatic renal cell carcinoma treated with cabozantinib and nivolumab, ALT elevations arose in 30 [63%] and to above 5 times ULN in 8 [17%] usually within the first month, all managed by dose reduction or interruption without high dose corticosteroids, and 5 of 7 patients who were rechallenged tolerated the drug). 40319472

## OTHER REFERENCE LINKS

1. Recent References on Cabozantinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Cabozantinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Cabozantinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cabozantinib)